# Phenobarbital

## OVERVIEW

### Introduction

Phenobarbital is a barbiturate that is widely used as a sedative and an antiseizure medication. Phenobarbital has been linked to rare instances of idiosyncratic liver injury that can be severe and even fatal.

### Background

Phenobarbital (fee" noe bar' bi tal) is a barbiturate and is believed to act as a nonselective depressant. Phenobarbital also has anticonvulsant activity and is thought to act by suppressing spread of seizure activity by enhancing the effect of gamma aminobutyric acid (GABA), raising the seizure threshold. Phenobarbital was introduced into clinical medicine in 1911 but was never subjected to critical controlled studies to demonstrate safety and efficacy. For these reasons, phenobarbital is now considered of unproven benefit in controlling seizures. Nevertheless, it is commonly used for prevention and management of partial and generalized seizures, usually as an adjunctive agent in combination with other anticonvulsants. Phenobarbital is also used for sedation and insomnia although its use for these conditions is now uncommon. Phenobarbital is also used in fixed combinations with other antispasmodics or anticholinergic agents and used for gastrointestinal complaints, including irritable bowel syndrome. The typical starting dose in treating seizures in adults is 60 to 100 mg in three divided doses daily. Oral formulations of tablets or capsules of 15, 16, 30, 60, 90 and 100 mg are available in multiple generic forms. Parenteral formations and oral elixirs for pediatric use are also available. Phenobarbital has declined in general use in recent years with availability of more efficacious and better tolerated agents. Its major advantage is low cost, but it is more sedating than other anticonvulsants. Frequent side effects include drowsiness, sedation, hypotension, and skin rash. Uncommon but potentially severe adverse events included severe sedation, dependence, hypersensitivity reactions, Stevens-Johnson syndrome and toxic epidermal necrolysis.

### Hepatotoxicity

Prospective studies suggest that less than 1% of subjects develop elevations in serum aminotransferase levels during long term phenobarbital therapy. Clinically apparent hepatotoxicity from phenobarbital is rare but can be abrupt in onset, severe and even fatal. Phenobarbital hepatotoxicity typically occurs in the setting of anticonvulsant hypersensitivity syndrome with onset of fever, rash, facial edema, lymphadenopathy, elevations in white count and eosinophilia occurring 1 week to several months after starting therapy. Liver involvement is common, but is usually mild and anicteric and overshadowed by other features of hypersensitivity (rash, fever). In some cases, hepatic involvement is more prominent with marked elevations in serum enzyme levels, jaundice and even signs of hepatic failure. The typical pattern of serum enzyme elevations is mixed, but can be hepatocellular or cholestatic. Liver biopsy shows mixed hepatitis-cholestatic injury with prominence of eosinophils and occasionally granulomata. Re-exposure usually results in recurrence and should be avoided.

Likelihood score: B (likely rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of phenobarbital hepatotoxicity is thought to be hypersensitivity or an immunological response to a metabolically generated drug-protein complex.

### Outcome and Management

Phenobarbital hepatotoxicity is usually rapidly reversible with improvements beginning within 5 to 7 days of stopping the drug and being complete within 1 to 2 months. In cases of severe injury, progression to acute liver failure and death can occur. Corticosteroids have been used but with uncertain effectiveness. Prolonged cholestasis can occur, but chronic injury and vanishing bile duct syndrome have not been reported from phenobarbital therapy. Cross reactivity with other aromatic anticonvulsants (phenytoin, carbamazepine, primidone, and lamotrigine) is common but not invariable. Patients with hypersensitivity to phenobarbital should be monitored carefully if they are to start other aromatic anticonvulsants.

Drug Class: Anticonvulsants, Sedatives and Hypnotics

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Phenobarbital – Generic, Luminal® Sodium

DRUG CLASS

Anticonvulsants

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Phenobarbital)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Phenobarbital | 50-06-6 | C12-H12-N2-O3

## ANNOTATED BIBLIOGRAPHY

References updated: 30 July 2020

Abbreviations used: DRESS, drug rash with eosinophilia and systemic symptoms; SJS/TEN, Stevens-Johnson syndrome and toxic epidermal necrolysis.

Zimmerman HJ. Anticonvulsants. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 498-516. (Expert review of anticonvulsants and liver injury published in 1999; mentions that liver injury from phenobarbital is rare, but it has been implicated in at least 15 cases of clinically apparent injury, both hepatocellular and cholestatic).
Pirmohamed M, Leeder SJ. Anticonvulsant agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013: pp 423-41. (Review of anticonvulsant induced liver injury mentions that clinically apparent hepatotoxicity from phenobarbital is rare and that cross sensitivity to hepatic injury from other aromatic anticonvulsants occurs, but is not invariable).
Smith MD, Metcalf CS, Wilcox KS. Pharmacology of the epilepsies. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 303-26. (Textbook of pharmacology and therapeutics).
Birch CA. (1936). Jaundice due to phenobarbital. Lancet.
Welton DG. (1950). Exfoliative dermatitis and hepatitis due to phenobarbital. J Am Med Assoc. (25 year old pregnant woman developed rash, followed by facial and peripheral edema, itching, erythema, desquamation, and high fever 6 weeks after starting phenobarbital [white blood count 73,000, 32% eosinophils] and was jaundiced for a few weeks but ultimately recovered).
McGeachy TE, Bloomer WE. (1953). The phenobarbital sensitivity syndrome. Am J Med. (3 cases of severe phenobarbital reactions seen between 1933 and 1947; two men and one woman, ages 27 to 41 years, developing rash, desquamation, fever, delirium and jaundice within 1-2 weeks of starting drug; one instance was fatal).
Pagliaro L, Campesi G, Aguglia F. (1969). Barbiturate jaundice. Report of a case due to a barbital-containing drug, with positive rechallenge to phenobarbital. Gastroenterology. (31 year old woman developed rash, fever and facial edema after 2 doses of "barbital" and by 7 days developed jaundice [bilirubin 24.1 mg/dL, ALT 200 U/L, Alk P 15 BU] which was prolonged; rechallenge with phenobarbital caused recurrence of fever, rash and jaundice [19 mg/dL]; three biopsies were done, but vanishing bile duct syndrome was evidently not present).
Weisburst M, Self T, Peace R, Cooper J. (1976). Jaundice and rash associated with the use of phenobarbital and hydrochlorothiazide. South Med J. (18 year old woman developed rash followed by fever, anorexia, lymphadenopathy and jaundice [bilirubin 7.2 mg/dL, AST 250 U/L, Alk P 350 U/L], with rapid resolution although no mention of drug being stopped).
Evans WE, Self TH, Weisburst MR. (1976). Phenobarbital-induced hepatic dysfunction. Drug Intell Clin Pharm.
Thirunavukkaram S, Merk P, Fitzgerald JF. (1979). Near-fatal phenobarbital hepatotoxicity in an 8 year old male. Gastroenterology.
Shapiro PA, Antonioli DA, Peppercorn MA. (1980). Barbiturate-induced submassive hepatic necrosis. Am J Gastroenterol. (71 year old woman developed rash on phenytoin and was switched to mephobarbital and 3 months later developed anorexia and fatigue followed by jaundice 6 weeks later [bilirubin 5.3 mg/dL, ALT 837 U/L, Alk P 320 U/L], improved slowly but relapsed with restarting phenobarbital; biopsy showed submassive necrosis, ultimately recovering completely; no features of hypersensitivity).
Jacobi G, Thorbeck R, Ritz A, Janssen W, Schmidts HL. (1980). Fatal hepatotoxicity in child on phenobarbitone and sodium valproate. Lancet. (Child given valproate [36 mg/kg] and phenobarbital for 3 months developed confusion and coma [bilirubin 9.7 mg/dL, ALT 60 U/L, high ammonia and protime], ultimately dying; more likely due to valproate than phenobarbital hepatotoxicity).
Spielberg SP, Gordeon GB, Blake DA, Goldstein DA, Herlong HF. (1981). Predisposition to phenytoin hepatotoxicity assessed in vitro. N Engl J Med. (3 patients with phenytoin hepatotoxicity had dose dependent cytotoxicity of lymphocytes exposed to microsomal metabolized drug [arene oxides]; clinical onset arose 4, 4 and 1 week after starting phenytoin, with rash, fever and jaundice; [bilirubin 7.8, 11.5 and 0.5 g/dL, AST 790, 2340 and 62 U/L, eosinophils 9%, 10% and 10%], all 3 recovered).
Lane T, Peterson EA. (1984). Hepatitis as a manifestation of phenobarbital hypersensitivity. South Med J. (4 year old boy developed fever and rash about 1 week after starting phenobarbital and 1 week later was found to have ALT 273 U/L [no bilirubin reported], rapidly improving with stopping).
Knutsen AP, Anderson J, Satayaviboon S, Slavin RG. (1984). Immunologic aspects of phenobarbital hypersensitivity. J Pediatr. (Seven patients with hypersensitivity reactions arising 2-23 days after starting phenobarbital with fever and a pruritic rash which was confluent and desquamating; 2 patients had abnormal liver tests, but without jaundice; 3 had eosinophilia, 3 IgE elevations; 2 decreased C4 levels; several had positive lymphocyte stimulation tests to phenytoin or phenobarbital).
Fonseca JC, Azulay DR, Rozembau I, Azulay RD. (1984). Med Cutan Ibero Lat Am.
Kahn HD, Faguet GB, Agee JF, Middleton HM. (1984). Drug-induced liver injury. In vitro demonstration of hypersensitivity to both phenytoin and phenobarbital. Arch Intern Med. (16 year old girl developed fever, facial edema, lymphadenopathy and rash 3 weeks after starting phenobarbital and phenytoin; stopping phenytoin had no effect, but she improved with stopping phenobarbital and had positive lymphocyte stimulation tests to both).
Palomeque A, Doménech P, Martínez-Gutiérrez A, Lequerica P. (1986). An Esp Pediatr. (11 year old girl developed rash, fever, adenopathy, somnolence and facial edema 4 weeks after starting phenobarbital [bilirubin 6.7 to 42.8 mg/dL, ALK 1380 to 2980 U/L, Alk P 855 to 3146 U/L], with confluent necrosis and central collapse on liver biopsy, transient episode of aplastic anemia during recovery).
Shear NH, Spielberg SP. (1988). Anticonvulsant hypersensitivity syndrome: in vitro assessment of risk. J Clin Invest. (Lymphocyte cytotoxicity found in response to drug metabolites from 53 patients with hypersensitivity to anticonvulsants, including 35/36 to phenytoin, 22/27 to phenobarbital and 25/27 to carbamazepine; 51% had hepatitis).
Roberts EA, Spielberg SP, Goldbach M, Phillips MJ. (1990). Phenobarbital hepatotoxicity in an 8-month-old infant. J Hepatol. (8 month old boy with seizures given phenobarbital for 2 weeks developed rash followed by fever with eosinophilia, atypical lymphocytosis and jaundice [bilirubin 2.9 mg/dL, ALT 430 U/L, Alk P 135 U/L], slow recovery, positive lymphocyte cytotoxicity test).
Horsmans Y, Larrey D, Pessayre D, Rueff B, Degott C, Benhamou JP. (1991). Gastroenterol Clin Biol. (Atrium, a fixed combination of phenobarbital and two carbamates, was implicated in 4 cases of hepatotoxicity arising 1-4 months after starting [normal bilirubin, ALT 1.5-21 fold elevated] with mild symptoms of asthenia, but no fever or rash and resolving within 1-3 months of stopping).
Pariente EA, Mineur D. (1992). Gastroenterol Clin Biol. (Patient developed fatigue one month after starting Atrium and clomethacine [bilirubin normal, ALT 16.5 times ULN, GGT 10 times ULN, ANA 1:160], resolved with stopping but recurrence of fatigue, ALT elevation and ANA/SMA positivity with two rechallenges: HLA A1, A9, B8, B27).
Handfield-Jones SE, Jenkins RE, Whittaker SJ, Besse CP, McGibbon DH. (1993). The anticonvulsant hypersensitivity syndrome. Br J Dermatol. (3 cases of fever and rash arising 3, 4 and 10 weeks after starting phenytoin or carbamazepine; two required steroids; only 1 had hepatitis; one died of multiorgan failure, others switched to valproate or clobazam without recurrence).
Brocheriou I, Zafrani ES, Mavier P. (1993). Gastroenterol Clin Biol. (29 year old man developed jaundice after 7 months of Atrium therapy [also on valproate and phenobarbital] with abdominal pain and jaundice [bilirubin 10 mg/dL, ALT 200-4056 U/L, ANA 1:200], biopsy showed no fat, recurrence with rechallenge of Atrium, but not valproate).
Horsmans Y, Lannes D, Pessayre D, Larrey D. (1994). Possible association between poor metabolism of mephenytoin and hepatotoxicity caused by Atrium, a fixed combination preparation containing phenobarbital, febarbamate and difebarbamate. J Hepatol. (Hydroxylation index of mephenytoin [CYP 2C] was assessed in 24 patients with drug induced hepatitis, found index higher [12.4] in 3 patients with Atrium hepatitis than in controls [1.8] and other patients [2.5], attributed abnormality to a defect in mephenytoin oxidation).
Di Martino V, Mallat A, Duvoux C, Zafrani ES, Dhumeaux D. (1994). Gastroenterol Clin Biol. (Patient on phenobarbital for 1 month developed fever and rash followed by adenopathy and jaundice [bilirubin 8.7 mg/dL, ALT 22 times ULN, elevated protime], treated with prednisone and recovered within 1 month).
Schneider S, Charles F, Chichmanian RM, Montoya ML, Rampal P. (1995). Gastroenterol Clin Biol. (37 year woman developed abdominal pain 6 months after starting Atrium [bilirubin 2.0 mg/dL, ALT 9 times ULN, Alk P 0.8 times ULN, ANA 1:1000], biopsy showed microvesicular fat; also taking carbimazole and phenytoin).
Cayla JM, Fandi L, Arnould P, Degott C, Gouffier E. (1995). Presse Med. (65 year old woman was found to have ALT elevations [5 times ULN] 3 months after starting Atrium, with rapid resolution on stopping and recurrence with rechallenge; no jaundice but some fatigue).
Wallace SJ. (1996). A comparative review of the adverse effects of anticonvulsants in children with epilepsy. Drug Saf. (Systematic review; ALT elevations occur in 4% of children on phenytoin, 6% on valproate, 1% on carbamazepine but not with phenobarbital; mentions that severe skin reactions and Stevens-Johnson syndrome have been linked to phenobarbital use).
Schlienger RG, Shear NH. (1998). Antiepileptic drug hypersensitivity syndrome. Epilepsia. (Review of anticonvulsant hypersensitivity syndrome; onset 2-8 weeks after starting therapy with aromatic anticonvulsants presenting with high fever, rash, adenopathy and pharyngitis followed by organ involvement, most commonly the liver [~50%], but also hematologic, renal or pulmonary; eosinophilia, blood dyscrasias, nephritis; sometimes facial edema, oral ulcers, hepatosplenomegaly, myopathy, disseminated intravascular coagulation, atypical lymphocytosis; rash usually exanthema with pruritus, occasional follicular pustules or exfoliative dermatitis and erythroderma, erythema multiforme, Stevens-Johnson syndrome or toxic epidermal necrolysis).
Knowles SR, Shapiro LE, Shear NH. (1999). Anticonvulsant hypersensitivity syndrome: incidence, prevention and management. Drug Saf. (Review of anticonvulsant hypersensitivity syndrome: triad of fever, rash and internal organ injury occurring 1-8 weeks after exposure to anticonvulsant; liver being most common internal organ involved. Occurs in 1:1000-1:10,000 initial exposures to phenytoin, carbamazepine, phenobarbital or lamotrigine, unrelated to dose, perhaps predisposed by valproate; liver injury arises 1-4 weeks after onset of rash and ranges in severity from asymptomatic ALT elevations to icteric hepatitis to acute liver failure. High mortality rate with jaundice; other organs include muscle, kidney, brain, heart and lung. Pseudolymphoma syndrome and serum sickness-like syndrome are separate complications of anticonvulsants. Role of corticosteroids uncertain; cross reactivity among the agents should be assumed).
Lachgar T, Touil Y. (2001). Allerg Immunol (Paris). (78 year old woman developed rash and fever 3 weeks after starting phenobarbital [ALT 3 times ULN, eosinophilia], resolving within a month of stopping).
Turner RB, Kim CC, Streams BN, Culpepper K, Haynes HA. (2004). Anticonvulsant hypersensitivity syndrome associated with Bellamine S, a therapy for menopausal symptoms. J Am Acad Dermatol. (Patient developed fever, rash and facial edema followed by jaundice 2 months after starting Bellamine S which contains phenobarbital, belladonna and ergotamine [bilirubin 2.4 mg/dL, ALT 97 U/L, Alk P 160 U/L, 14% eosinophils], and then developed complications of herpes zoster and meningitis during prednisone therapy for the hypersensitivity, and later had recurrence during carbamazepine therapy for neuralgia).
Autret-Leca E, Norbert K, Bensouda-Grimaldi L, Jonville-Béra AP, Saliba E, Bentata J, Barthez-Carpentier MA. (2007). Arch Pediatr. (6 year old girl with epilepsy developed rash, fever and eosinophilia 3 weeks after starting phenobarbital [ALT 5 times ULN, Alk P 1.5 times ULN], improving clinically with corticosteroid therapy; switched to topiramate and valproate without recurrence).
Tohyama M, Hashimoto K, Yasukawa M, et al. (2007). Association of human herpes virus 6 reactivation with the flaring and severity of drug-induced hypersensitivity syndrome. Br J Dermatol. (Anti-HHV-6 testing of 100 patients with drug induced hypersensitivity syndrome [34% with hepatitis] found rise in IgG levels in 62 patients, largely in more severe cases; HHV-6 DNA detected in 18; drugs included carbamazepine, phenobarbital, phenytoin, allopurinol, sulfasalazine and mexiletine).
Di Mizio G, Gambardella A, Labate A, Perna A, Ricci P, Quattrone A. (2007). Hepatonecrosis and cholangitis related to long-term phenobarbital therapy: an autopsy report of two patients. Seizure. (Two men, ages 44 and 40 years, on long term phenobarbital had sudden death and were found to have granulomas and portal inflammation on autopsy).
Björnsson E. (2008). Hepatotoxicity associated with antiepileptic drugs. Acta Neurol Scand. (Review of anticonvulsant hepatotoxicity, mentions that phenytoin associated liver injury usually occurs as a part of a hypersensitivity syndrome, in 1:10,000 to 1:50,000 persons, 100 published cases, mean onset at 4 weeks, 13% mortality; in contrast, phenobarbital has only rarely been reported to cause liver injury).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, 18 cases were attributed to anticonvulsants, no case was attributed to phenobarbital).
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. (2010). Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol. (Worldwide pharmacovigilance database contained 9036 hepatic adverse drug reactions in children, phenobarbital accounting for 41 cases [0.4%] for an adjusted odds ratio of 6.6).
Molleston JP, Fontana RJ, Lopez MJ, Kleiner DE, Gu J, Chalasani N, Drug-Induced Liver Injury Network. (2011). Characteristics of idiosyncratic drug-induced liver injury in children: results from the DILIN Prospective Study. J Pediatr Gastroenterol Nutr. (Among 30 children with drug induced liver injury enrolled in a prospective US database between 2004 and 2008, 8 were due to anticonvulsants [lamotrigine in 3, valproate in 3, phenytoin in 1 and carbamazepine in 1], none were attributed to phenobarbital).
Zhang LL, Zeng LN, Li YP. (2011). Side effects of phenobarbital in epilepsy: a systematic review. Epileptic Disord. (Review of the side effects of phenobarbital focusing upon cognitive adverse effects).
(2013). Drugs for epilepsy. Treat Guidel Med Lett. (Concise review and guidelines to use of anticonvulsants; phenobarbital is listed under "other drugs" and said to be effective for partial and secondarily generalized tonic-clonic seizures; no mention of hepatotoxicity).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, including 1 attributed to phenytoin among only 410 persons receiving the drug in Iceland; none were attributed to phenobarbital).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, 7 [4%] of which were attributed to anticonvulsants including 3 to phenytoin, 3 to valproate and 1 to carbamazepine, but none were attributed to phenobarbital).
Devarbhavi H, Andrade RJ. (2014). Drug-induced liver injury due to antimicrobials, central nervous system agents, and nonsteroidal anti-inflammatory drugs. Semin Liver Dis. (Review of drug induced liver injury caused by several drug classes including antiepileptics, which account for 2-11% of all cases in various registries; a common presentation is with DRESS, particularly with the older agents such as carbamazepine, phenytoin and phenobarbital and often associated with reactivation of human herpes virus 6 or 7).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 40 [4.5%] were due to anticonvulsants including 12 due to phenytoin, 9 lamotrigine, 7 valproate, 4 carbamazepine, 3 gabapentin, 2 topiramate and 1 each for ethosuximide, fosphenytoin, and pregabalin; but none were attributed to phenobarbital).
Chalasani N, Reddy KRK, Fontana RJ, Barnhart H, Gu J, Hayashi PH, Ahmad J, Stolz A, Navarro V, Hoofnagle JH. (2017). Idiosyncratic drug induced liver injury in African-Americans is associated with greater morbidity and mortality compared to Caucasians. Am J Gastroenterol. (Among subjects enrolled in a US prospective database of drug induced liver injury, causes more frequent in African Americans than Caucasian were trimethoprim/sulfamethoxazole, methyldopa, phenytoin and allopurinol, and African Americans were more likely to have severe skin adverse events [2.1% vs 0.4%], fatal or transplantation outcomes [10% vs 6%] as well as chronic injury [24% vs 16%]).
Vidaurre J, Gedela S, Yarosz S. (2017). Antiepileptic drugs and liver disease. Pediatr Neurol. (Review of the use of anticonvulsants in patients with liver disease recommends use of agents that have little hepatic metabolism such as levetiracetam, lacosamide, topiramate, gabapentin and pregabalin, levetiracetam being an "ideal" first line therapy for patients with liver disease because of its safety and lack of pharmacokinetic interactions).
(2017). Drugs for epilepsy. Med Lett Drugs Ther. (Concise review of the drugs available for therapy of epilepsy mentions that phenobarbital and primidone are effects for therapy of partial and secondarily generalized tonic-clonic seizures, but have a higher incidence of sedation that other drugs).
Borrelli EP, Lee EY, Descoteaux AM, Kogut SJ, Caffrey AR. (2018). Stevens-Johnson syndrome and toxic epidermal necrolysis with antiepileptic drugs: An analysis of the US Food and Drug Administration Adverse Event Reporting System. Epilepsia. (Review of adverse event reports to the FDA between 2014 and 2018 identified ~2.9 million reports, 1034 for SJS/TEN, the most common class of drugs being anticonvulsants with 17 of 34 having at least one report, those most frequently linked being lamotrigine [n=106], carbamazepine [22], levetiracetam [14], phenytoin [14], valproate [9], clonazepam [8] and zonisamide [7], whereas phenobarbital is not listed; no mention of accompanying liver injury).
Han XD, Koh MJ, Wong SMY. (2019). Drug reaction with eosinophilia and systemic symptoms in a cohort of Asian children. Pediatr Dermatol. (Among 10 children with DRESS syndrome seen at a single, Singapore referral center between 2006 and 2016, 3 cases were attributed to sulfamethoxazole/trimethoprim, 2 to carbamazepine, 1 sulfasalazine, 2 phenobarbital and 1 to levetiracetam [latency 28 days]; all had ALT elevations [88 to 1172 U/L], bilirubin was elevated in 7, but none had acute liver failure and none were fatal).
Cano-Paniagua A, Amariles P, Angulo N, Restrepo-Garay M. (2019). Epidemiology of drug-induced liver injury in a University Hospital from Colombia: Updated RUCAM being used for prospective causality assessment. Ann Hepatol. (Among 286 patients with liver test abnormalities seen in a single hospital in Colombia over a 1 year period, 17 were diagnosed with drug induced liver injury, the most common cause being antituberculosis therapy [n=6] followed by anticonvulsants [n=3, 1 each due to phenytoin, gabapentin and valproate]).
Sridharan K, Daylami AA, Ajjawi R, Ajooz HAMA. (2020). Drug-induced liver injury in critically ill children taking antiepileptic drugs: a retrospective study. Curr Ther Res Clin Exp. (Among 41 children admitted to a pediatric intensive care unit who received anticonvulsants for seizure control, 5 of 9 receiving phenobarbital alone, 9 of 12 receiving phenytoin alone but none of six receiving valproate developed liver test abnormalities [all hepatocellular], the timing, height and outcome of which were not given).
Sharpe C, Reiner GE, Davis SL, Nespeca M, Gold JJ, Rasmussen M, Kuperman R, et al. (2020). NEOLEV2 INVESTIGATORS. Levetiracetam versus phenobarbital for neonatal seizures: a randomized controlled trial. Pediatrics. (Among 83 newborns with seizures of any caused treated with intravenous phenobarbital or levetiracetam for 5 days, seizure-free status at 24 hours was achieved more frequently with phenobarbital [80% vs 38%] which also had more frequent side effects; monitoring of laboratory data demonstrated “no significant treatment-emergent trends”).

## OTHER REFERENCE LINKS

1 Recent References on Phenobarbital: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(phenobarbital/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%222009/11/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Phenobarbital: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=phenobarbital)